# Erenumab

## OVERVIEW

### Introduction

Erenumab is a monoclonal antibody to the receptor for calcitonin gene related peptide which plays a role in inducing migraine headaches. Erenumab is used for prevention of migraine in patients with episodic or chronic migraine headaches. Erenumab therapy has not been associated with serum enzyme elevations during therapy nor has it been implicated in cases of clinically apparent drug induced liver injury with jaundice.

### Background

Erenumab (e ren' ue mab) is a recombinant, human monoclonal IgG1 antibody to the calcitonin gene related peptide (CGRP) receptor which plays an important role in migraine headaches. CGRP is a neuropeptide found throughout the central and peripheral nervous systems which has potent vasodilator and pain signaling activities. Circulating levels of CGRP are elevated in patients with migraines, and the efficacy of migraine therapies (serotonin receptor agonists, ergot alkaloids) is associated with lowering of CGRP levels. Erenumab inhibits the CGRP receptor blocking the subsequent downstream activation of the intracellular signaling pathways. In several prospective controlled trials, erenumab given subcutaneously every 4 weeks was shown to decrease the migraine frequency in adult patients with frequent and poorly controlled migraine headaches. Erenumab was approved for use in the United States in 2018 as a means of prevention of migraine headaches. Erenumab in available in solution in single use prefilled syringes or autoinjectors of 70 mg under the brand name Aimovig. The recommended dose is 70 mg subcutaneously once monthly. Erenumab is not effective as therapy of acute migraine and lowers the frequency but typically does not abolish all episodes. Side effects of erenumab are uncommon but can include injection site reactions and constipation. Erenumab has not been associated with significant numbers of severe adverse events, however it has had limited general use and the effects of long term suppression of CGRP signaling are unknown but could theoretically increase the rate of serious cardiovascular or cerebrovascular ischemic events.

### Hepatotoxicity

In large clinical trials, erenumab was not associated with changes in serum aminotransferase levels during therapy and rates of most adverse reactions were similar to those in patients who received placebo. There have been no published reports of clinically apparent acute liver injury attributed to erenumab therapy. Thus, significant liver injury from erenumab must be very rare if it occurs at all.

Likelihood score: E (unlikely cause of clinically apparent liver injury).

### Mechanism of Liver Injury

Erenumab is a human monoclonal antibody and is unlikely to be inherently hepatotoxic. While most recombinant proteins are metabolized by the liver, the metabolism leads largely to small peptides and amino acids which may be reused to synthesize proteins and are unlikely to be toxic or immunogenic.

Drug Class: Migraine Headache Agents, Monoclonal Antibodies

## PRODUCT INFORMATION

REPRESENTATIVE TRADE NAMES

Erenumab – Aimovig®

DRUG CLASS

Migraine Headache Agents

COMPLETE LABELING (https://dailymed.nlm.nih.gov/dailymed/search.cfm?labeltype=all&query=Erenumab)

Product labeling at DailyMed, National Library of Medicine, NIH

## CHEMICAL FORMULA AND STRUCTURE

DRUG | CAS REGISTRY NUMBER | MOLECULAR FORMULA | STRUCTURE
Erenumab | 1582205-90-0 | Monoclonal Antibody | Not Available

## ANNOTATED BIBLIOGRAPHY

References updated: 08 August 2018

Zimmerman HJ. Drugs used to treat rheumatic and musculospastic disease. In, Zimmerman HJ. Hepatotoxicity: the adverse effects of drugs and other chemicals on the liver. 2nd ed. Philadelphia: Lippincott, 1999, pp. 517-54. (Expert review of hepatotoxicity published in 1999, well before the availability of most monoclonal antibody therapies).
Reuben A. Hepatotoxicity of immunosuppressive drugs. In, Kaplowitz N, DeLeve LD, eds. Drug-induced liver disease. 3rd ed. Amsterdam: Elsevier, 2011, pp. 569-91. (Review of hepatotoxicity of immunosuppressive agents; "the biological immuno-suppressants are largely free from hepatotoxicity, with the exception of the TNF alpha antagonists"; erenumab is not discussed).
https://www.accessdata.fda.gov/scripts/cder/daf/ (FDA Drug Approvals website that has product labels [package inserts], letters of approval and full FDA scientific review of the new drug application for safety and efficacy).
Goadsby PJ, Reuter U, Hallström Y, Broessner G, Bonner JH, Zhang F, Sapra S, et al. A controlled trial of erenumab for episodic migraine. N Engl J Med 2017; 377: 2123-32. PubMed Citation (https://www.ncbi.nlm.nih.gov/pubmed/29171821) (Among 955 patients with frequent migraine headaches treated with erenumab [70 or 140 mg] or placebo injections once monthly for 6 months, migraine frequency decreased more with erenumab therapy and there were no differences in adverse event rates among the 3 groups, including “no clinically meaningful differences…with regard to the results of hepatic-function testing…” with no patients developing ALT or AST elevations above 5 times ULN during therapy).
Tepper S, Ashina M, Reuter U, Brandes JL, Doležil D, Silberstein S, Winner P, et al. Safety and efficacy of erenumab for preventive treatment of chronic migraine: a randomised, double-blind, placebo-controlled phase 2 trial. Lancet Neurol 2017; 16: 425-34. PubMed Citation (https://www.ncbi.nlm.nih.gov/pubmed/28460892) (Among 667 patients with chronic migraine treated with erenumab [70 or 140 mg] or placebo every 4 weeks for 12 weeks, monthly migraine days decreased more with erenumab [-6.6 vs -4.2 days] and adverse event rates were similar in all 3 groups, one person on erenumab had a transient mild elevation of serum aminotransferase levels, but there were “no clinically significant abnormalities in…laboratory values…”).
Ashina M, Dodick D, Goadsby PJ, Reuter U, Silberstein S, Zhang F, Gage JR, et al. Erenumab (AMG 334) in episodic migraine: Interim analysis of an ongoing open-label study. Neurology 2017; 89: 1237-43. PubMed Citation (https://www.ncbi.nlm.nih.gov/pubmed/28835404) (Among 472 patients enrolled in open label extension trials of erenumab demonstrated the frequency of migraine headache was reduced for more than a year without new safety concerns and “there were no clinically significant changes in viral signs, laboratory values or ECG findings”).
Erenumab (Aimovig) for migraine prevention. Med Lett Drugs Ther 2018; 60 (1549): 101-3. PubMed Citation (https://www.ncbi.nlm.nih.gov/pubmed/29913472) (Concise review of the mechanism of action, clinical efficacy, safety and costs of erenumab shortly after its approval for use in the US; mentions minor side effects of injection site reactions and constipation, but makes no mention of ALT elevations or hepatotoxicity).
Edvinsson L. The CGRP pathway in migraine as a viable target for therapies. Headache 2018; 58 Suppl 1: 33-47. PubMed Citation (https://www.ncbi.nlm.nih.gov/pubmed/29697153) (Review of the calcitonin gene related peptide [CGRP] and its receptor including their relationship to migraine headaches and development of small molecular inhibitors and monoclonal antibody therapies based upon their inhibition).
Dodick DW, Ashina M, Brandes JL, Kudrow D, Lanteri-Minet M, Osipova V, Palmer K, et al. ARISE: A Phase 3 randomized trial of erenumab for episodic migraine. Cephalalgia 2018; 38: 1026-37. PubMed Citation (https://www.ncbi.nlm.nih.gov/pubmed/29471679) (Among 577 patients with episodic migraine treated with erenumab or placebo, monthly migraine days decreased more with erenumab [-2.9 vs -1.8 days]; overall adverse event rates were similar [48% vs 55%] and there were no liver related serious adverse events; no mention of changes in ALT levels or hepatotoxicity).

## OTHER REFERENCE LINKS

1. Recent References on Erenumab: from PubMed.gov (https://www.ncbi.nlm.nih.gov/sites/entrez?cmd=search&db=pubmed&pubmedfilters=true&term=(theophylline/AE)+AND+Human%5BMH%5D+AND+(drug+induced+liver+injury+OR+jaundice/CI+OR+bile+duct+diseases/CI+OR+liver/DE+OR+liver+diseases/CI)+AND+(%221900/1/1%22%5BEDat%5D%3A%222999/12/31%22%5BEDat%5D))
2. Trials on Erenumab: from ClinicalTrials.gov (https://clinicaltrials.gov/ct2/results?term=theophylline)